# Antiandrogens

## OVERVIEW

The antiandrogens are medications that act by binding to intracellular androgen receptors, preventing the effects of endogenous androgens on target tissues such as testes, hair follicles, hypothalamus, pituitary, ovaries and prostate gland. The antiandrogens are used for a variety of hyperandrogenic states such as acne, hirsutism, and paraphilias, but their major use is in therapy of prostate cancer. Chemically, antiandrogens are classified into steroidal (such as cyproterone acetate) and nonsteroidal (including flutamide, nilutamide and bicalutamide). Cyproterone, despite evaluation in many clinical trials, has yet to receive FDA approval for use the United States, largely because of its potential for hepatotoxicity. In contrast, flutamide, nilutamide and bicalutamide are now approved and in general clinical use for therapy of prostate cancer. The largest and longest clinical experience has been with flutamide which has been shown to produce clinical remission in patients with prostate cancer, and is also used in hyperandrogenic states including acne and hirsutism. Nilutamide has been extensively studied and is indicated for use in combination with surgical castration for the treatment of metastatic prostate cancer and is recommended to be started at the time of orchiectomy. Unlike flutamide, nilutamide has not been evaluated in detail as therapy of hirsutism or acne. Bicalutamide, the most recent antiandrogen to be approved for use in the United States, is also used in therapy of prostate cancer, but has not been approved for use in nonmalignant hyperandrogenic states.

All three nonsteroidal antiandrogens have been linked to instances of liver injury. Minor asymptomatic elevations in serum aminotransferase levels occur in 10% to 62% of patients on long term antiandrogen therapy, and prominent elevations (3 to 5 times the ULN) in 1% to 10%, the rates being somewhat higher for flutamide than nilutamide or bicalutamide. Instances of acute hepatitis with jaundice and even acute liver failure have been reported with all three antiandrogens. While most reports have related to flutamide, this may be due to its more extensive use. The rate of clinically apparent acute liver injury during prolonged antiandrogen therapy is reported to be as high as 9%, but is probably in the range of 0.1% to 1%. Screening for serum aminotransferase levels during the first few months of therapy is often recommended, but the effectiveness of this approach in preventing serious liver injury and death has not been shown.

Abiraterone is a more recently developed antiandrogen used to treat prostate cancer. Abiraterone is a steroid inhibitor of CYP17, an enzyme in the pathway of androgen production which has been shown to be effective in prolonging relapse free and overall survival in men with metastatic, castration-resistant prostate cancer. Abiraterone has been linked to a moderate rate of serum aminotransferasae elevations during therapy, but the abnormalities are usually mild and transient, and instances of clinically apparent liver injury have not been linked to use of this agent, although its general use has been limited.

Each of the antiandrogens is discussed separately with individual clinical cases and references. The following are links to each drug record.

- Abiraterone
- Apalutamide
- Bicalutamide
- Cyproterone
- Enzalutamide
- Flutamide
- Nilutamide

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Abiraterone | 154229-19-3 | C24-H31-N-O | Abiraterone chemical structure
Bicalutamide | 90357-06-5 | C18-H14-F4-N2-O4-S | Bicalutamide chemical structure
Flutamide | 13311-84-7 | C11-H11-F3-N2-O3 | Flutamide chemical structure
Nilutamide | 63612-50-0 | C12-H10-F3-N3-O4 | Nilutamide chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2014

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 699. (Expert review of hepatotoxicity published in 1999, mentions that flutamide has led to instances of severe hepatic necrosis and fulminant hepatic failure).
DeLeve LD. Flutamide. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier. 2013. pp. 559. (Textbook on drug induced liver injury mentions that flutamide has been implicated in at least 46 cases of severe liver injury with 20 fatalities).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics; discusses the role of androgen receptor blockers in prostate cancer including bicalutamide, flutamide and nilutamide).
Meijers WH, Willemse PH, Sleijfer DT, Mulder NH, Grond J. Hepatocellular damage by cyproterone acetate. Eur J Cancer Clin Oncol 1986; 22: 1121-2. (In a study of 20 women with breast cancer, cyproterone was given in dose of 200-400 mg/day for 6 to 52 weeks; 5 developed ALT elevations, and two had acute hepatitis after 11 and 21 weeks, with ALT >10 times ULN and liver biopsies showing confluent necrosis). 2946585
Lévesque H, Trivalle C, Manchon ND, Vinel JP, Moore N, Hémet J, Courtois H, et al. Fulminant hepatitis due to cyproterone acetate. Lancet 1989; 1: 215-6. (78 year old man with prostate cancer developed jaundice 5 months after starting cyproterone [bilirubin 10.4 mg/dL, ALT 1015 U/L, Alk P 153 U/L], progressing to hepatic failure and death within 2 weeks of initial presentation). 2563116
Parys BT, Hamid S, Thomson RG. Severe hepatocellular dysfunction following cyproterone acetate therapy. Br J Urol 1991; 67: 312-3. (3 case reports of jaundice developing in men [ages 65 to 83 years] with prostate cancer given cyproterone for 9-12 months [bilirubin 19, 10.4, and 16.4 mg/dL; AST 254, 377 and 155 U/L; Alk P 218, 252 and 79 U/L], resolving within 12 weeks of stopping in 1 but progression to liver failure and death in the other 2 patients). 1827039
McLeod DG. Tolerability of nonsteroidal antiandrogens in the treatment of advanced prostate cancer. Oncologist 1997; 2: 18-27. (Overview of the safety and side effects of the nonsteroidal antiandrogens; ALT elevations occur in 5-10% receiving drug vs 1-3% with placebo; clinically apparent hepatitis can occur and can be fatal; estimated rates being 3/10,000 treated). 10388026
Friedman G, Lamoureux E, Sherker AH. Fatal fulminant hepatic failure due to cyproterone acetate. Dig Dis Sci 1999; 44: 1362-3. (81 and 66 year old men with prostate cancer developed jaundice 7 and 8 months after starting cyproterone [bilirubin 30 and 12.2 mg/dL, ALT 395 and 702 U/L, Alk P 376 and 144 U/L], with progression and fatal outcome in both. Review of 7 published cases; onset 2-15 [mean=8] months, bilirubin 9-30 times ULN, all hepatocellular). 10489919
Pu YS, Liu CM, Kao JH, Chen J, Lai MK. Antiandrogen hepatotoxicity in patients with chronic viral hepatitis. Eur Urol 1999; 36: 293-7. (Retrospective study of 121 men receiving antiandrogen therapy with flutamide or cyproterone found abnormal ALT levels in most or all who were HBsAg or anti-HCV positive; but many were not tested and frequency of ALT monitoring was unclear. Authors propose that antiandrogen hepatotoxicity is more frequent among men with preexisting hepatitis B or C, but no attempt was made to separate hepatotoxicity from exacerbation of underlying disease). 10473987
Lin AD, Chen KK, Lin AT, Chang YH, Wu HH, Kuo JY, Huang WJ, et al. Antiandrogen-associated hepatotoxicity in the management of advanced prostate cancer. J Chin Med Assoc 2003; 66: 735-40. (Retrospective review of 229 patients with prostate cancer treated with flutamide or cyproterone combined with a luteinizing hormone-releasing hormone agonist, orchiectomy or radiotherapy with regular monitoring of ALT: ALT >2 times ULN occurred in 15% of flutamide and 9.5% CPA recipients; ALT >6 times ULN in 5% vs 4%; no deaths, a few had jaundice). 15015823
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to an antiandrogen, perhaps because patients with prostate cancer would not be eligible for liver transplantation). 15390328
Thole Z, Manso G, Salgueiro E, Revuelta P, Hidalgo A. Hepatotoxicity induced by antiandrogens: a review of the literature. Urol Int 2004; 73: 289-95. Review. (Systematic review of the literature from the Spanish pharmacovigilance group; 21 reports of hepatotoxicity from cyproterone, 46 flutamide, 4 nilumidine, only 1 bicalutamide; 6 cases of hepatocellular carcinoma linked to cyproterone therapy). 15604569
Manso G, Thole Z, Salgueiro E, Revuelta P, Hidalgo A. Spontaneous reporting of hepatotoxicity associated with antiandrogens: data from the Spanish pharmacovigilance system. Pharmacoepidemiol Drug Saf 2006; 15: 253-9. (Analysis of spontaneous reporting to Spanish Pharmacovigilance system found 88 cases of flutamide, 11 bicalutamide and 15 cyproterone hepatotoxicity, latency 3-6 months; 2 fatalities, both from flutamide). 16294367
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; flutamide ranked 11th with a total of 59 cases) . 16054882
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiandrogen). 18955056
Merwat SN, Kabbani W, Adler DG. Fulminant hepatic failure due to nilutamide hepatotoxicity. Dig Dis Sci 2009; 54: 910-3. (76 year old man with prostate cancer developed abdominal pain followed by jaundice 6 weeks after starting nilutamide [bilirubin 25.8 mg/dL, ALT 1793 U/L, Alk P 231 U/L, INR 1.7], followed by progressive hepatic and multiorgan failure and death). 18688719
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 25 from antituberculosis drugs, 9 from sulfonamides, 12 from nitrofurantoin, 6 from antifungal agents, 11 from antiepileptic drugs, and 12 from herbals, but none were attributed to antiandrogen therapies). 20949552
Brahm J, Brahm M, Segovia R, Latorre R, Zapata R, Poniachik J, Buckel E, Contreras L. Acute and fulminant hepatitis induced by flutamide: case series report and review of the literature. Ann Hepatol 2011; 10: 93-8. (Analysis of 10 patients with flutamide hepatotoxicity seen at a single institution in Chile included 3 men [ages 67-80 with prostate cancer] and 7 women [ages 20-44 with hirsutism], onset after 40 to 180 days, 9 with jaundice [bilirubin 2.4 to 44 mg/dL, ALT 159 to 3360 U/L], 5 progressed to acute liver failure requiring liver transplantation [all women]). 21301018
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 18 due to cyproterone and 12 to flutamide, 11 from Chile [10 in Brahm 2011] and 1 from Colombia).24552865
Ryan CJ, Smith MR, Fizazi K, Saad F, Mulders PF, Sternberg CN, Miller K, et al.; COU-AA-302 Investigators. Abiraterone acetate plus prednisone versus placebo plus prednisone in chemotherapy-naive men with metastatic castration-resistant prostate cancer (COU-AA-302): final overall survival analysis of a randomised, double-blind, placebo-controlled phase 3 study. Lancet Oncol 2015; 16: 152-60. (Among 1088 patients with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone vs prednisone alone, side effects included mild ALT elevations [13% vs 5%] that were rarely greater than 5 times ULN [0.7% vs 0%] and there were no instances of clinically apparent liver injury or liver related deaths). 25601341

## OTHER REFERENCE LINKS

1. Recent References on Antiandrogens: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=androgen+antagonists/AE+AND+human%5Bmh%5D+AND+(liver+diseases/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+jaundice/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222006/4/15%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Antiandrogens: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=antiandrogens)